# Troglitazone

## OVERVIEW

### Introduction

Troglitazone was the first thiazolidinedione approved for use in the United States and was licensed for use in type 2 diabetes in 1997, but withdrawn 3 years later because of the frequency of liver injury including acute liver failure associated with its use.

### Background

Troglitazone (troe gli' ta zone) is an insulin sensitizing agent thought to act by engagement of PPAR-γ receptors which induce multiple genes involved in glucose and fatty acid metabolism. In clinical trials, troglitazone was found to lower blood glucose and HbA1c levels and had additive effects with the sulfonylureas and metformin. Troglitazone was approved for use in the United States in 1997 to be used alone or in combination with other antidiabetic medications. However, reports of severe liver injury and death from acute liver failure began to arise soon after its general availability, and it was withdrawn from use in 2000. Troglitazone was sold under the brand name Rezulin and was available in 400 mg tablets. The recommended dosage was 400 to 800 mg once daily. Troglitazone was used as monotherapy as well as in combination with metformin, sulfonylureas or insulin.

### Hepatotoxicity

Large prospective studies showed that significant elevations in serum aminotransferase levels (equal to or greater than 3 times the upper limit of the normal range [ULN]) occurred in 1.9% of patients with diabetes treated with troglitazone for 24 to 48 weeks, compared to only 0.6% in placebo recipients. These enzyme elevations were usually asymptomatic and often resolved despite continuation of therapy. Nevertheless, elevations >10 times ULN occurred in 0.5% of patients (but in no placebo recipient) and a proportion of these developed symptoms of liver injury and jaundice. Soon after the approval of troglitazone as therapy for type 2 diabetes in the United States, cases of severe acute liver injury began to be reported, and dramatic case reports as well as small case series documented that clinically significant injury was occurring in 1:1000 to 1:10,000 recipients. The latency to onset of injury was typically 1 to 6 months and the onset was marked by fatigue, weakness, dark urine and jaundice, and an acute hepatitis-like elevation in serum enzymes (hepatocellular pattern). Allergic phenomena (rash, fever, eosinophilia) were uncommon and serum autoantibodies were not usually present. Liver biopsies showed acute inflammatory changes and variable degrees of necrosis, ranging from rare spotty necrosis to bridging hepatic necrosis and submassive or massive necrosis. At least two dozen cases of acute liver failure and death or need for liver transplantation were reported to the FDA before troglitazone was withdrawn from use in 2000.

Likelihood score: A (well recognized cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of liver injury due to troglitazone is unknown. Signs and symptoms of allergic and immune reactivity are rare and a metabolic defect in its metabolism is suspected to be the cause. Troglitazone is a potent inducer of CYP 3A4 and has a distinctive alpha tocopherol (vitamin E-like) side chain which can be metabolized to a highly active quinolone-like metabolite, which may account for its occasional aberrant metabolism and hepatotoxicity.

### Outcome and Management

The liver injury from troglitazone can be severe and even fatal. In several cases there was incomplete recovery at the time of the last follow up evaluation, suggesting that the injury can become chronic in some instances. Prednisone has been reported to have a beneficial effect, but only in anecdotal reports. While several patients with mild troglitazone liver injury were later treated with other thiazolidinediones without recurrence of injury, other patients have developed worsening liver injury; switching therapy to other thiazolidinediones is inadvisable and, if done, should be with careful monitoring of serum aminotransferase levels.

References to safety and hepatotoxicity of troglitazone are given together with references to the related agents in the Overview section on the Thiazolidinediones (updated June 2018).

Drug Class: Antidiabetic Agents

Other Drugs in the Subclass, Thiazolidinediones: Pioglitazone, Rosiglitazone

## CASE REPORT

### Case 1. Acute hepatitis arising after 4 months of troglitazone therapy.

[Modified from: Shiano T, Dolehide K, Hart J, Baker AL. Severe but reversible hepatitis induced by troglitazone. Dig Dis Sci 2000; 45: 1039-42. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/10795774)]

A 63 year old man with diabetes was started on troglitazone (20 mg daily) and was hospitalized 18 weeks later with marked jaundice. Other medical problems included a distant history of alcohol use, type 2 diabetes for 4 years for which he took glipizide, a history of abdominal aortic aneurysm, and hypercholesterolemia for which he took pravastatin. On admission, he was markedly jaundiced and complained of pruritus and fatigue, but had no signs of liver failure (Table). Tests for hepatitis A, B and C were negative as were serum autoantibodies. A liver biopsy showed changes of acute hepatitis consistent with drug induced liver injury. Ultrasound and CT scans showed no evidence of gallstones or biliary obstruction. Troglitazone was stopped and he recovered slowly.

#### Key Points

Medication: | Troglitazone (20 mg/day for 18 weeks)
Pattern: | Hepatocellular (R=17)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 4-5 months
Recovery: | 3-5 months
Other medications: | Aspirin (81 mg daily), vitamin E (5000 U/day), pravastatin (20 mg/day), glipizide (5 mg/day)

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
18 weeks | 0 | 1961 | 213 | 13.2 | GGT 168 U/L; protime normal
20 weeks | 2 weeks | 358 | 168 | 36.9
6 months | 6 weeks | 218 | 146 | 13.9
10 months | 6 months | Normal | Normal | Normal
Normal Values | | <66 | <126 | <1.2

#### Comment

Acute hepatocellular injury without signs of allergy (fever, eosinophilia and rash) developed between 4 and 5 months after starting troglitazone. No other cause of acute liver injury was identified and a liver biopsy was consistent with drug induced hepatitis. The patient became markedly jaundiced and was severely symptomatic with pruritus, fatigue and weight loss, but he did not develop evidence of hepatic failure and eventually recovered fully. The difference between a reversible and irreversible severe liver injury may well depend upon how rapidly therapy is withdrawn after onset.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Troglitazone – Rezulin® (Withdrawn from U.S. Market)

DRUG CLASS

Hypoglycemic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=troglitazone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Troglitazone | 97322-87-7 | C24-H27-N-O5-S | Troglitazone chemical structure

## OTHER REFERENCE LINKS

1. Recent References on Troglitazone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(troglitazone/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Troglitazone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=troglitazone)